# Alemtuzumab

## OVERVIEW

### Introduction

Alemtuzumab is a recombinant human monoclonal antibody to human CD52 which is used in the therapy of chronic lymphocytic leukemia, in induction regimens for solid organ transplantation, and for resistant forms of relapsing multiple sclerosis. Alemtuzumab has not been linked to serum aminotransferase elevations during therapy but has been implicated in rare cases of clinically apparent liver injury as well as reactivation of chronic hepatitis B and exacerbations of chronic hepatitis C that can be severe and even fatal.

### Background

Alemtuzumab (al” em tooz’ ue mab) is a recombinant, human IgG1 kappa monoclonal antibody which is directed at and binds avidly to the human cell surface marker CD52 which is present on T and B cells, monocytes, macrophages and other bone marrow cells. Alemtuzumab therapy leads to depletion of lymphocytes with suppression of B cells for 6 to 12 months and T cells for 12 to 24 months. Alemtuzumab was approved in the United States in 2004 for use in chronic lymphocytic leukemia (CLL). It has also been used extensively off-label as a part of induction therapy for prevention of rejection after solid organ transplantation and treatment of several autoimmune diseases. In 2017, indications were extended to include resistant relapsing multiple sclerosis. Alemtuzumab is available in single use vials of 30 mg/mL under the brand name Campath for CLL and Lemtrada for multiple sclerosis. The typical dose and regimen varies with indication, but it is generally given in two courses of 3 to 5 days of daily intravenous infusions one year apart. Premedication with corticosteroids is recommended as well as herpes virus prophylaxis. Alemtuzumab has significant adverse side effects, largely due to the profound and prolonged immunosuppression that it induces. Alemtuzumab is available only as a part of a Risk Evaluation and Mitigation Strategy (REMS) program that requires health care deliverer training and careful monitoring of patients for side effects. Common adverse events include fever, headache, fatigue, nausea, abdominal pain, chest pain, hypertension, rhinitis, dry skin, back pain, excessive bleeding, epistaxis, and skin rash. Less common, but serious complications include severe infusions reactions, cytopenias (including fatal autoimmune anemia and thrombocytopenia), autoimmune reconstitution syndromes (including Graves disease, autoimmune thrombocytopenia and neutropenia, sarcoidosis, and Goodpasture syndrome), acalculous cholecystitis, both hemorrhagic and ischemic strokes, opportunistic infections, and increased risk of malignancies.

### Hepatotoxicity

In large clinical trials, alemtuzumab therapy was associated with a high rate of side effects including serious infusion reactions, infections and bone marrow suppression, but hepatotoxicity and serum ALT elevations were rarely mentioned in the clinical trials of its use. Since its approval and more widespread use in multiple sclerosis, however, several instances of serum aminotransferase elevations as well as acute, clinically apparent liver injury have been reported with alemtuzumab therapy usually arising within a few weeks or months of the initial infusion. Severe episodes have been reported, but the injury usually resembles an immune mediated reaction and responses to corticosteroid therapy which eventually can be withdrawn without recurrence.

Strikingly, however, trials of alemtuzumab in multiple sclerosis reported high rates of autoimmune and autoinflammatory conditions arising in up to 48% of patients 6 to 36 months after a cycle of infusions. The autoimmune condition most frequently implicated is Graves disease, reported in 20% to 30% of patients who were followed long term after treatment with alemtuzumab. Less commonly reported are autoimmune thrombocytopenia and Goodpasture syndrome which like Graves disease are considered due to B-cell autoimmunity. Rarely reported conditions include sarcoidosis, hemophagocytic lymphohistiocytosis, autoimmune anemia and neutropenia, acquired Factor VII deficiency, lupus erythematosus, Addison disease, and acalculous cholecystitis. Autoimmune hepatitis has also been reported after alemtuzumab therapy of multiple sclerosis. Complicating this association, however, is the fact that autoimmune hepatitis is not uncommon in patients with multiple sclerosis independent of treatment. Nevertheless, idiosyncratic liver disease with autoimmune features has been reported often enough for it to be listed as a warning on product labels for alemtuzumab. The cause of these late onset abnormalities appears to be the imbalance in reconstitution of immune function after the profound and prolonged immunosuppression caused by alemtuzumab. Thus, pathogenic autoreactive B cells accompanied by autoantibodies return while there is still a relative deficiency in regulatory T cells that usually suppress or modulate autoimmune reactions.

In addition, alemtuzumab is a potent immunosuppressive agent and predisposes to opportunistic bacterial, viral, fungal and viral infections including reactivation of hepatitis B and C as well as adventitious viral infections such as cytomegalovirus, herpes zoster virus, herpes simplex, and others which can be associated with hepatic injury. Importantly, multiple instances of reactivation of hepatitis B have been reported in patients with HBsAg in serum who were treated with this monoclonal antibody. In addition, some patients with anti-HBc without HBsAg in serum have developed HBV reactivation with reappearance of HBsAg (reverse seroconversion) after alemtuzumab therapy. These episodes can be severe and fatal instances have been reported. Finally, exacerbation and possibly reactivation of hepatitis C has been described in patients receiving alemtuzumab therapy.

Likelihood score: B (likely rare cause of clinically apparent liver injury as well as reactivation of hepatitis B).

### Mechanism of Injury

Alemtuzumab is a monoclonal antibody and, while metabolized in the liver, is metabolized to small peptides and amino acids that are not likely to be immunogenic or toxic. The immunosuppression caused by alemtuzumab, on the other hand, may cause reactivation of hepatitis B and exacerbations of chronic hepatitis C. Furthermore, withdrawal of alemtuzumab and reconstitution of the immune system may account for the rare instance of an autoimmune hepatitis as B and T cell function begins to return 6 to 36 months after the monoclonal antibody infusion. Episodes of acute hepatitis arising soon after the initial infusion of alemtuzumab may have a different pathogenesis but is also likely due to immunosuppression.

### Outcome and Management

Alemtuzumab appears to have little intrinsic hepatotoxicity and idiosyncratic liver injury must be very rare, if it occurs at all. In contrast, alemtuzumab is capable of causing reconstitution autoimmune reactions as well as reactivation of hepatitis B and worsening of hepatitis C. For these reasons, it is appropriate to screen patients for hepatitis B and C infection before starting therapy, and providing prophylaxis or treatment of these viral infections before or concurrent with starting monoclonal antibody therapy. Furthermore, monitoring of routine liver tests before starting therapy and “periodically thereafter” is recommended.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies; Transplant Agents; Multiple Sclerosis Agents

Other Drugs in the Subclass, Transplant Agents, Monoclonal Antibodies: Basiliximab, Daclizumab, Muromonab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Alemtuzumab – Campath®, Lemtrada®

DRUG CLASS

Antineoplastic Agents, Monoclonal Antibodies

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Alemtuzumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Alemtuzumab | 216503-57-0 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 30 September 2025

Abbreviations: CLL, chronic lymphocytic leukemia; CMV, cytomegalovirus.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents, mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; no specific discussion of alemtuzumab).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
Krensky AM, Azzi JR, Hafler DA. Immunotherapy for multiple sclerosis. Immunosuppressants and tolerogens. In, Brunton LL, Hilal-Dandan, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 649-652. (Textbook of pharmacology and therapeutics).
Coles AJ, Wing M, Smith S, Coraddu F, Greer S, Taylor C, Weetman A, et al. Pulsed monoclonal antibody treatment and autoimmune thyroid disease in multiple sclerosis. Lancet 1999; 354(9191): 1691-5. (Among 27 patients with multiple sclerosis given a 5 day course of alemtuzumab and followed for 18 months, 9 [33%] developed Graves disease [2 with ophthalmopathy] and antibodies to thyrotropin receptor, an autoimmune response not seen with alemtuzumab therapy of other conditions including rheumatoid arthritis). 10568572
Rai KR, Freter CE, Mercier RJ, Cooper MR, Mitchell BS, Stadtmauer EA, Santábarbara P, et al. Alemtuzumab in previously treated chronic lymphocytic leukemia patients who also had received fludarabine. J Clin Oncol 2002; 20: 3891-7. (Among 24 patients with resistant CLL treated with alemtuzumab, all [100%] developed infusion reactions and ten [41%] severe, opportunistic infections including 4 with pneumocystis jirovecii pneumonia; no mention of ALT elevations, hepatitis or hepatotoxicity). 12228210
Marcos A, Eghtesad B, Fung JJ, Fontes P, Patel K, Devera M, Marsh W, et al. Use of alemtuzumab and tacrolimus monotherapy for cadaveric liver transplantation: with particular reference to hepatitis C virus. Transplantation 2004; 78: 966-71. (Among 76 adults undergoing liver transplantation who received induction therapy with alemtuzumab, subsequent rates of rejection, graft loss, death and adverse reactions were similar to a cohort of 84 contemporaneous transplant recipients; no mention of hepatotoxicity). 15480160
Tzakis AG, Tryphonopoulos P, Kato T, Nishida S, Levi DM, Madariaga JR, Gaynor JJ, et al. Preliminary experience with alemtuzumab (Campath-1H) and low-dose tacrolimus immunosuppression in adult liver transplantation. Transplantation 2004; 77: 1209-14. (Among 40 adults undergoing liver transplantation who received induction therapy with alemtuzumab and low dose tacrolimus, subsequent rates of graft loss, death and adverse reactions were similar to a cohort of 50 contemporaneous transplant recipients given conventional immunosuppressive therapy; routine liver test results were similar between the two groups). 15114087
Heider U, Fleissner C, Zavrski I, Jakob C, Dietzel T, Eucker J, Ockenga J, et al. Treatment of refractory chronic lymphocytic leukemia with Campath-1H in combination with lamivudine in chronic hepatitis B infection. Eur J Haematol 2004; 72: 64-6. (69 year old man with CLL and anti-HBc without HBsAg in serum developed reactivation of hepatitis B after chemotherapy with CHOP, rituximab and fludarabine that responded to lamivudine therapy and did not worsen when he was subsequently treated with alemtuzumab). 14962266
Iannitto E, Minardi V, Calvaruso G, Mulè A, Ammatuna E, Di Trapani R, Ferraro D, et al. Hepatitis B virus reactivation and alemtuzumab therapy. Eur J Haematol 2005; 74: 254-8. (Two patients with CLL with anti-HBc without HBsAg in serum developed reactivation of hepatitis B with alemtuzumab therapy, one 4 weeks after starting and one 5 months after alemtuzumab treatment and two months after withdrawal of lamivudine prophylaxis; both recovered with antiviral therapy). 15693796
Cortelezzi A, Viganò M, Zilioli VR, Fantini NN, Pasquini MC, Deliliers GL, Colombo M, et al. Adefovir added to lamivudine for hepatitis B recurrent infection in refractory B-cell chronic lymphocytic leukemia on prolonged therapy with Campath-1H. J Clin Virol 2006; 35: 467-9. (49 year old man with CLL and anti-HBc without HBsAg in serum developed severe reactivation of HBV after treatment with high doses of chlorambucil, responding to lamivudine and adefovir therapy, and without rise in HBV DNA levels during subsequent rescue therapy with alemtuzumab). 16316778
Moses SE, Lim ZY, Sudhanva M, Devereux S, Ho AY, Pagliuca A, Zuckerman M, et al. Lamivudine prophylaxis and treatment of hepatitis B Virus-exposed recipients receiving reduced intensity conditioning hematopoietic stem cell transplants with alemtuzumab. J Med Virol 2006; 78: 1560-3. (Among 8 alemtuzumab treated bone marrow transplant recipients who had anti-HBc without HBsAg in serum, reactivation occurred in 1 of 2 patients who did not receive prophylaxis, but in none of 6 who did receive prophylactic lamivudine). 17063522
Fiegl M, Falkner A, Hopfinger G, Brugger S, Zabernigg A, Bauer F, Haslbauer F, et al.; Austrian Collaborative Study Group on Alemtuzumab in Chronic Lymphocytic Leukemia. Routine clinical use of alemtuzumab in patients with heavily pretreated B-cell chronic lymphocytic leukemia: a nation-wide retrospective study in Austria. Cancer 2006; 107: 2408-16. (Retrospective analysis of results of alemtuzumab therapy in 115 patients with CLL reported side effects of severe infections in 51%, severe neutropenia in 26%, and severe hypersensitivity reactions in 8%, but did not mention ALT elevations or hepatotoxicity). 17054106
Magliocca JF, Knechtle SJ. The evolving role of alemtuzumab(Campath-1H) for immunosuppressive therapy in organ transplantation. Transpl Int 2006; 19: 705-14. (Review of efficacy of alemtuzumab in various forms of organ transplantation; no discussion of ALT elevations or hepatotoxicity). 16918530
James DF, Kipps TJ. Alemtuzumab in chronic lymphocytic leukemia. Future Oncol 2007; 3: 29-42. (Review of history of development, clinical efficacy and toxicity of alemtuzumab as therapy of CLL, no mention of hepatotoxicity or ALT elevations). 17280499
Hillmen P, Skotnicki AB, Robak T, Jaksic B, Dmoszynska A, Wu J, Sirard C, et al. Alemtuzumab compared with chlorambucil as first-line therapy for chronic lymphocytic leukemia. J Clin Oncol 2007; 25: 5616-23. (Among 297 patients with chronic lymphocytic leukemia treated with alemtuzumab or chlorambucil, adverse events included infusion reactions, cytomegalovirus [CMV] infections, anemia and neutropenia; no mention of ALT elevations or hepatotoxicity). 17984186
Demko S, Summers J, Keegan P, Pazdur R. FDA drug approval summary: Alemtuzumab as single-agent treatment for B-cell chronic lymphocytic leukemia. Oncologist 2008; 13: 167-74. (Independent FDA review of studies in support of alemtuzumab as therapy of chronic lymphocytic leukemia listed common side effects including infusion reactions [87%], CMV viremia [56%], neutropenia [14%] and anemia [13%]; no mention of hepatotoxicity or ALT elevations). 18305062
Hui CK, Cheung WW, Leung KW, Cheng VC, Tang BS, Li IW, Luk JM et al. Retracted: outcome and immune reconstitution of HBV-specific immunity in patients with reactivation of occult HBV infection after alemtuzumab-containing chemotherapy regimen. Hepatology 2008; 48: 1-10. (Among 21 patients with HBV DNA without HBsAg in serum [17 with anti-HBc] treated with alemtuzumab chemotherapy, 6 developed reactivation of hepatitis B with reappearance of HBsAg in all and rise in liver enzymes in 5, despite early intervention with lamivudine therapy; this article was later retracted). 18452145
Alemtuzumab (Campath) off-label for relapsing multiple sclerosis. Med Lett Drugs Ther 2009; 51(1307) 17-8. (Discussion of the off-label use of alemtuzumab for relapsing multiple sclerosis mentions that side effects include infusion reactions, autoimmune thyroid disorders and thrombocytopenic purpura, but does not mention ALT elevations or clinically apparent hepatotoxicity).
Dhesi S, Boland B, Colquhoun S. Alemtuzumab and liver transplantation: a review. Curr Opin Organ Transplant 2009; 14: 245-9. (Short review of induction therapy using alemtuzumab in preparation of liver transplantation summarizing results from two US studies suggesting lower rates of rejection and ability to use lower doses of maintenance therapy). 19417659
Jones JL, Phuah CL, Cox AL, Thompson SA, Ban M, Shawcross J, Walton A, et al. IL-21 drives secondary autoimmunity in patients with multiple sclerosis, following therapeutic lymphocyte depletion with alemtuzumab (Campath-1H). J Clin Invest 2009; 119: 2052-61. (Analysis of lymphocyte function in patients with multiple sclerosis who develop reconstitution autoimmunity suggest that lymphocytes that proliferate after ablation by alemtuzumab are skewed towards self-reactivity and susceptible to apoptosis features that are promoted by high levels of IL21). 19546505
Cai J, Terasaki PI. Induction immunosuppression improves long-term graft and patient outcome in organ transplantation: an analysis of United Network for Organ Sharing registry data. Transplantation 2010; 90: 1511-5. (Since 2003, most solid organ transplant recipients have received induction therapy and analyses of the UNOS registry for this period shows highest rates of patient and graft survival with alemtuzumab [89% 5 year patient survival] as compared to antithymocyte globulin [89%], basiliximab [84%], daclizumab [77%], steroids [75%], or no induction [71%]). 21057388
Anoop P, Wotherspoon A, Matutes E. Severe liver dysfunction from hepatitis C virus reactivation following alemtuzumab treatment for chronic lymphocytic leukaemia. Br J Haematol 2010; 148: 484-6. (39 year old man with CLL had anti-HCV and normal ALT levels without HCV RNA in serum, but developed high levels of HCV RNA and ALT levels 34 days after starting weekly infusions of alemtuzumab and prednisone, not having had reactivation during rituximab or previous fludarabine and prednisone therapy). 19874308
Hanaway MJ, Woodle ES, Mulgaonkar S, Peddi VR, Kaufman DB, First MR, Croy R, et al. INTAC Study Group. Alemtuzumab induction in renal transplantation. N Engl J Med 2011; 364: 1909-19. (Among 474 patients undergoing renal transplantation and given alemtuzumab or convention induction therapy, acute rejection rates during the first 3 years were lower with alemtuzumab than basiliximab in low risk patients [15% vs 24%], but were similar with alemtuzumab and antithymocyte globulin in high risk patients [30% vs 24%]). 21591943
Kim SJ, Moon JH, Kim H, Kim JS, Hwang YY, Intragumtornchai T, Issaragrisil S, et al. Non-bacterial infections in Asian patients treated with alemtuzumab: a retrospective study of the Asian Lymphoma Study Group. Leuk Lymphoma 2012; 53: 1515-24. (Retrospective analysis of infectious complications among 182 patients treated with alemtuzumab between 2003-2009 in 6 Asian countries identified 66 cases of CMV, 25 varicella-zoster virus, 31 fungal infections, 4 pneumocystis jirovecii pneumonia, HBV reactivation 4 [in previously HBsAg negative patients], and tuberculosis 16). 22273250
Coles AJ, Twyman CL, Arnold DL, Cohen JA, Confavreux C, Fox EJ, Hartung HP, et al.; CARE-MS II investigators. Alemtuzumab for patients with relapsing multiple sclerosis after disease-modifying therapy: a randomised controlled phase 3 trial. Lancet 2012; 380(9856): 1829-39. (Among 798 patients with relapsing remitting multiple sclerosis treated with alemtuzumab [12 or 24 mg for 5 and 3 days at month 0 and 12] or interferon beta-1a [44 mcg three times weekly], relapse rates were lower with alemtuzumab [35% vs 53%] and adverse event rates were slightly higher [77% vs 69%], particularly for autoimmune thyroid abnormalities [16% and 19% vs 5%] and autoimmune thrombocytopenia [1% vs none]; while liver toxicity was reported in 3-4% vs 6%], details of which were not provide). 23122650
Costelloe L, Jones J, Coles A. Secondary autoimmune diseases following alemtuzumab therapy for multiple sclerosis. Expert Rev Neurother 2012; 12: 335-41. (Review of the secondary autoimmune conditions associated with alemtuzumab therapy of multiple sclerosis including Graves disease in 12-33% of subjects, thrombocytopenic purpura in 1-3% and Goodpasture’s syndrome in <1%). 22364332
Putra J, Suriawinata AA. Adenovirus hepatitis presenting as tumoral lesions in an immunocompromised patient. Ann Hepatol 2014; 13: 827-9. (59 year old man with T-cell leukemia treated with alemtuzumab developed fever and adenovirus hepatitis, responding to cidofovir therapy). 25332270
Di Bisceglie AM, Lok AS, Martin P, Terrault N, Perrillo RP, Hoofnagle JH. Recent US Food and Drug Administration warnings on hepatitis B reactivation with immune-suppressing and anticancer drugs: just the tip of the iceberg? Hepatology 2015; 61: 703-11. (Review of the pathogenesis, clinical course, treatment and prevention of HBV reactivation in patients receiving immunosuppressive or anticancer therapies, with particular focus on rituximab and ofatumumab). 25412906
Tuohy O, Costelloe L, Hill-Cawthorne G, Bjornson I, Harding K, Robertson N, May K, et al. Alemtuzumab treatment of multiple sclerosis: long-term safety and efficacy. J Neurol Neurosurg Psychiatry. 2015;86:208-15.. (Among 87 adults with multiple sclerosis treated with alemtuzumab between 1999 and 2012 at a single UK referral center, 52% required only two 2 cycles, but 45% required 3 or more; in long term follow up [median of 7 years] secondary autoimmunity arose in 41 patients [48%], mostly thyroid conditions [n=35], but less commonly thrombocytopenic purpura [3] and single cases of autoimmune neutropenia, hemolytic anemia, and Goodpasture’s syndrome [eventually requiring renal transplantation] most cases occurring within 2 years and all within 5 years of last cycle). 24849515
Pfeuffer S, Beuker C, Ruck T, Lenze F, Wiendl H, Melzer N, Meuth SG. Acute cholecystitis during treatment with alemtuzumab in 3 patients with RRMS. Neurology. 2016;87:2380-2381.. (3 adults with multiple sclerosis developed acute abdominal pain on day 3 of an initial or second cycle of alemtuzumab with elevations in AST but not Alk P, no gallstones or biliary dilation on imaging but edema or thickening of the gallbladder wall, responding rapidly to antibiotic therapy and medical management). 27794114
Croteau D, Flowers C, Kulick CG, Brinker A, Kortepeter CM. Acute acalculous cholecystitis: A new safety risk for patients with MS treated with alemtuzumab. Neurology. 2018;90:e1548-e1552.. (Among 8 reports of acute acalculous cholecystitis attributed to alemtuzumab made to the Food and Drug Administration , 7 arose during the period of infusions and resolved spontaneously with conservative management without corticosteroids or surgery. abstract only). 29602912
Baker D, Herrod SS, Alvarez-Gonzalez C, Giovannoni G, Schmierer K. Interpreting lymphocyte reconstitution data from the pivotal phase 3 trials of alemtuzumab. JAMA Neurol 2017; 74: 961-9. (Analysis of depletion and reconstitution of B and T cell subsets after alemtuzumab therapy suggests that the secondary autoimmunity is due to rebound in autoreactive B cells with relative deficiency in T cell regulatory function). 28604916
Willis MD, Hope-Gill B, Flood-Page P, Joseph F, Needham E, Jones J, Coles A, Robertson NP. Sarcoidosis following alemtuzumab treatment for multiple sclerosis. Mult Scler 2018; 24: 1779-82. (Among 187 patients with multiple sclerosis treated with alemtuzumab, 3 developed sarcoidosis, 2 to 4 years after the last infusion). 30307364
El Sankari S, Dahlqvist G, Monino L, van Pesch V. Auto-immune hepatitis in a patient with multiple sclerosis treated with alemtuzumab. Acta Neurol Belg 2018; 118: 331-3. (25 year old woman with multiple sclerosis developed Graves disease 11 months after a second course of alemtuzumab and liver injury 1 month after starting thiamazole for the hyperthyroidism [bilirubin 14 times ULN, ALT 5 times ULN], not responding to stopping antithyroid drug but improving with prednisone therapy). 29713905
Filippi M, Bar-Or A, Piehl F, Preziosa P, Solari A, Vukusic S, Rocca MA. Multiple sclerosis. Nat Rev Dis Primers. 2018;4:43. (Review of the pathogenesis, clinical features, natural history, management and therapy of multiple sclerosis). 30410033
Saarela M, Senthil K, Jones J, Tienari PJ, Soilu-Hänninen M, Airas L, Coles A, et al. Hemophagocytic lymphohistiocytosis in 2 patients with multiple sclerosis treated with alemtuzumab. Neurology. 2018;90:849-851.. (Two cases: 20 year old female with multiple sclerosis developed acalculous cholecystitis 1 year after a second cycle of alemtuzumab which was followed by cytopenias, abnormal liver enzymes, hemophagocytosis, and hepatic failure leading to death one month later; a 28 year old man with multiple sclerosis developed fever, abdominal pain, and bleeding episodes with acquired factor VIII hemophilia, a bone marrow biopsy showing erythrophagocytic histiocytes with mild liver test abnormalities that responded to corticosteroids and rituximab). 29602914
Holmøy T, Fevang B, Olsen DB, Spigset O, Bø L. Adverse events with fatal outcome associated with alemtuzumab treatment in multiple sclerosis. BMC Res Notes 2019; 12: 497. (Systematic review of the literature and of adverse event databases identified 9 cases of alemtuzumab-attributed severe adverse events leading to death, including 1 case of autoimmune hepatitis arising a year after therapy; no further details given). 31405369
Beattie W, Yan B, Sood S. Acute severe hepatitis with alemtuzumab and rechallenge after a year. J Clin Neurosci 2019; 60: 158-60. (49 year old woman with relapsing remitting multiple sclerosis developed test abnormalities within 2 days of starting alemtuzumab and methylprednisolone [bilirubin 0.7 mg/dL, ALT 378 rising to 577 U/L, Alk P 87], which resolved within 4 weeks and had recurrence with a second course 12 months later [bilirubin normal, ALT 400 rising to 700] again resolving within 4 weeks). 30348589
Antonazzo IC, Poluzzi E, Forcesi E, Riise T, Bjornevik K, Baldin E, Muratori L, et al. Liver injury with drugs used for multiple sclerosis: a contemporary analysis of the FDA Adverse Event Reporting System. Mult Scler. 2019;25:1633-1640. PIMD: 30230957. (Among 4873 cases of severe liver injury attributed to agents used to treat multiple sclerosis reported to the FDA’s Adverse Event Reporting System between 2004 and 2016, the most frequently implicated agents were interferon-beta 1a [n=2343], natalizumab [n=759], interferon beta 1b [535], fingolimod [496], dimethyl fumarate [223], glatimer acetate [212], teriflunomide [158], mitoxantrone [199], and alemtuzumab [93].
Romero A, Midaglia L, Salcedo MT, Viladomiu L, Guillén E, Bajaña I, Escolà-Vergé L, et al. Hemophagocytic syndrome following alemtuzumab treatment for multiple sclerosis: A case report. Mult Scler Relat Disord. 2020;40:101973.. (44 year old man with multiple sclerosis developed rash, fever, and jaundice 1 month after a second course of yearly alemtuzumab [bilirubin 19.7 mg/dL, ALT 299, Alk P 799] biopsy suggesting hemophagocytic syndrome which responded to methylprednisolone). 32028116
Drugs for multiple sclerosis. Med Lett Drugs Ther. 2021;63(1620):42–8.. (Concise review of the relative clinical efficacy, safety and costs of drugs for relapsing multiple sclerosis including parenteral agents [such as interferon-beta, glatiramer acetate, natalizumab, alemtuzumab, ocrelizumab, ofatumumab, rituximab and mitoxantrone] and the oral agents [such as the S1P receptor modulators, cladribine, fumarates, and teriflunomide], many of which are associated with serum ALT elevations and several have been reported to cause clinically apparent liver injury or reactivation of hepatitis B). 33976089
Bolte FJ, Schmidt HH, Schlevogt B. Immune-mediated hepatitis induced by therapy with alemtuzumab in a patient with multiple sclerosis. Hepatology. 2021;73:460-463.. (36 year old woman with multiple sclerosis developed ALT elevations after the initial course of alemtuzumab [bilirubin 0.8 mg/dL, ALT 599 U/L, Alk P 106 U/L,INR 0.9] responding to corticosteroids and a more severe episode after the second course 1 year later [bilirubin 3.2 mg/dL, ALT 5389 U/L, Alk P 86, INR 5.4] with 3 additional episodes when corticosteroids were tapered or stopped eventually needing maintenance therapy with mycophenolate and then cyclosporine). 32583445
Biolato M, Bianco A, Lucchini M, Gasbarrini A, Mirabella M, Grieco A. The disease-modifying therapies of relapsing-remitting multiple sclerosis and liver injury: a narrative review. CNS Drugs. 2021;35:861-880.. (Extensive review of the frequency and characteristics of hepatic injury associated with different disease modifying drugs for multiple sclerosis, mentions that elevations in serum aminotransferase levels arise in 5% of treated patients but are generally transient and mild, but that rare instances of acute liver injury with autoimmune features have been reported). 34319570
Rauma I, Mustonen T, Seppä JM, Ukkonen M, Männikkö M, Verkkoniemi-Ahola A, Kartau M, et al. Safety of alemtuzumab in a nationwide cohort of Finnish multiple sclerosis patients. J Neurol. 2022;269:824-835.. (Among 121 patients with multiple sclerosis treated with alemtuzumab in Finland between 2013 and 2019 with a median follow up of 30 months, 95% had an adverse event [84% with acute infusion reactions], 32% [n=37] had serious adverse events, including 2 with liver injury [1 with suspected autoimmune hepatitis and 1 with eosinophilic cholangitis of unclear cause], and 1 each with hemophagocytic lymphohistocytosis [fatal], thrombotic thrombocytopenic purpura [TTP], and type 1 diabetes), 3 other patients developed acalculous cholecystitis, 2 at the time of the third infusion in cycle one and in another 1 year after the cycle 2. 34255182
Ošep AB, Brecl E, Škerget M, Savšek L. An unforeseen reality: Hemophagocytic lymphohistiocytosis following alemtuzumab treatment for a multiple sclerosis. Clin Neurol Neurosurg. 2023;228:107675.. (19 year old female with multiple sclerosis developed thyroiditis 7 months after an initial cycle of alemtuzumab and hemophagocytic lymphocytosis 11 months after a second cycle presenting with rash, fever, chest pain, and cough and with elevations in liver tests [values not given] as well as hyperferritinemia and cytopenia, responding to methylprednisolone and anakinra). 36965418
Ng HS, Zhu F, Zhao Y, Yao S, Lu X, Ekuma O, Evans C, Fisk JD, Marrie RA, Tremlett H. Adverse Events associated with disease-modifying drugs for multiple sclerosis: a multiregional population-based study. Neurology. 2024;102:e208006.. (Among 35,894 people from 4 Canadian provinces who received therapy for multiple sclerosis and had available health data there was an increased risk for incident chronic liver disease in patients on teriflunomide and acute liver injury in those on dimethyl fumarate, but rates of acute liver injury on alemtuzumab were too few [<6 in among 222 patient-years] to calculate risk). 38181306
Chiu CY, Brumble LM, Vikram HR, Watt KD, Beam E. Hepatitis B virus reactivation in non-liver solid organ transplantation: incidence and risk analysis. Clin Transplant. 2024;38:e15389.. (Among 180 solid organ [non-liver] transplants in patients with HBsAg [n=71] or anti-HBc without HBsag [n=109], 14 developed reactivation of HBV, all of whom did not receive prophylaxis with antiviral therapy, arising in 2 of 6 with HBsAg and 12 of 97 with anti-HBc without HBsAg; 4 of the 14 having received an induction regimen with alemtuzumab). 38952185
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, one case was attributed to fingolimod and one to natalizumab, but no other agents used to treat multiple sclerosis were listed: personal communication). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Alemtuzumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Alemtuzumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Alemtuzumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Alemtuzumab)